# Ba Jiao Lian

## OVERVIEW

### Introduction

Ba Jiao Lian is an herb derived from Dysosma pleianthus, a species of mayapple found in China, which has been used for thousands of years in Chinese medicine. Ba Jiao Lian has been implicated in a generalized toxicity marked by nausea, abdominal pain, bone marrow suppression, confusion and accompanying liver injury.

### Background

Ba Jiao Lian has been used in Chinese medicine for centuries as a general remedy and for treatment of weakness, venereal disease, tumors and snakebite. Similarly, Native Americans often used the root extracts of the indigenous North American mayapple plant (podophyllum peltatum) as a laxative and for other disorders. Ba Jiao Lian has been implicated in a generalized toxicity marked by gastrointestinal, bone marrow, neurological and hepatic injury, which is believed to be due to podophyllum, a major ingredient in the herb. Podophyllum comprises several glycosides, the most toxic of which is podophyllotoxin. Podophyllum is also used in Western medicine topically to treat warts, and chemical modifications of podophyllotoxin have been developed as anticancer agents (etoposide and teniposide). While it was used for centuries in traditional Chinese medicine, Ba Jiao Lian is inherently toxic and, when taken in high enough doses, causes a distinctive clinical syndrome of nausea, diarrhea and vomiting followed by confusion, stupor, and coma with fever, leukocytosis, thrombocytopenia, abnormal liver tests and sensory-motor and autonomic neuropathy.

### Hepatotoxicity

Ba Jiao Lian causes a toxic syndrome that includes abnormal liver tests, although the other symptoms overshadow the liver injury and most patients have not developed jaundice or hepatic failure. In cases of intoxication reported from Asia, patients have had minimal elevations (1 to 3 times the upper limit of the normal range) in serum aminotransferase levels, with AST usually higher than ALT and no jaundice. Indeed, muscle and other organ injury may account for some of the serum enzyme elevations in Ba Jiao Lian toxicity.

Likelihood score: B (likely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of hepatotoxicity of Ba Jiao Lian is likely due to podophyllotoxin, which is contained in variable concentrations in the (unripe) fruit, foliage, stems and roots of the mayapple plant. The podophyllum glycosides are directly toxic to cells.

### Outcome and Management

Hepatotoxicity from Ba Jiao Lian is mild and greatly overshadowed by its gastrointestinal, bone marrow and neurologic toxicity.

Drug Class: Herbal and Dietary Supplements; see also Chinese and Other Asian Herbal Medicines

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ba Jiao Lian – Generic

DRUG CLASS

Herbal and Dietary Supplements

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Podophyllotoxin | 518-28-5 ID: JW05850000 | C22-H22-O8 Herbal mixture

## ANNOTATED BIBLIOGRAPHY

References updated: 24 May 2022

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; hepatotoxicity of Chinese herbal products and teas are discussed generally without focus on any specific product or herb).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbal and dietary supplements [HDS] discusses Chinese and other Asian herbal medicines and teas, but not Ba Jiao Lian).
Mayapple [Podophyllum peltatum]. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007. (Compilation of short monographs on herbal medications and dietary supplements; has a section on mayapple, but not ba jiao or dysosma).
Kao WF, Hung DZ, Tsai WJ, Lin KP, Deng JF. (1992). Podophyllotoxin intoxication: toxic effect of Bajiaolian in herbal therapeutics. Hum Exp Toxicol. (5 patients with Bajiaolian toxicity presenting with nausea, diarrhea, abdominal pain, abnormal liver tests [bilirubin normal, ALT 43-66 U/L, AST 52-183, Alk P usually normal], thrombocytopenia, sensory and motor neuropathy consistent with podophyllotoxin intoxication).
Stickel F, Seitz HK, Hahn EG, Schuppan D. (2001). Z Gastroenterol. (Review of hepatotoxicity of botanicals including pyrrolizidine alkaloids, germander, celandine, chaparral, Chinese herbs and pennyroyal; Ba Jiao Lian and podophyllum are not discussed).
Schiano TD. (2003). Hepatotoxicity and complementary and alternative medicines. Clin Liver Dis. (Comprehensive review of herbal associated hepatotoxicity, including common patterns of presentation with discussion of Chinese herbal medicines, including Jin Bu Huan, Ma Huang, Shou Wu Pian, and Sho-Saiko-To; Ba Jiao Lian is listed as hepatotoxic).
Pittler MH, Ernest E. (2003). Systematic review: hepatotoxic events associated with herbal medicinal products. Aliment Pharmacol Ther. (Systematic review of published cases of hepatotoxicity due to herbal medications, listing 52 case reports or case series, most common agents being celandine [3], chaparral [3], germander [8], Jin Bu Huan [3], kava [1], Ma huang [3], pennyroyal [1], skullcap [2], Chinese herbs [9], valerian [1]).
García-Cortés M, Borraz Y, Lucena MI, Peláez G, Salmerón J, Diago M, Martínez-Sierra MC, et al. (2008). Liver injury induced by “natural remedies”: an analysis of cases submitted to the Spanish Liver Toxicity Registry. Rev Esp Enferm Dig. (Among 521 cases of drug induced liver injury submitted to Spanish registry, 13 [2%] were due to herbals, including Camellia sinensis [green tea], Cassia angustifolia [senna], kava, valerian, Rhamnus purshianus [cascara], fitosoja [soy plant], biosoja [soy extract], Aesculus hippocatanum [horse chestnut], chitosan [deacetylated chitin] and Couterea latifloral [Copalchi]).
Navarro VJ. (2009). Herbal and dietary supplement hepatotoxicity. Semin Liver Dis. (Overview of the regulatory environment, clinical patterns, and future directions in research with HDS including traditional Chinese herbal medicines and usnic acid; Ba Jiao Lian is not discussed).
Chou SL, Chou MY, Kao WF, Yen DH, Yen LY, Huang CI, Lee CH. (2010). Bajiaolian poisoning-a poisoning with high misdiagnostic rate. Am J Emerg Med. (Review of records of 4 poison centers in Taiwan from 1985 to 2003 identified 17 cases of Ba Jiao Lian toxicity, 15 were initially misdiagnosed; presenting with nausea, weakness, confusion, gastrointestinal bleeding, and abnormal liver tests followed by sensory-motor and autonomic neuropathy).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, of which 12 were attributed to herbals, but none specifically to Ba Jiao Lian).
Stickel F, Kessebohm K, Weimann R, Seitz HK. (2011). Review of liver injury associated with dietary supplements. Liver Int. (Review of current understanding of liver injury from herbals and dietary supplements focusing upon Herbalife and Hydroxycut products, green tea, usnic acid, Noni juice, Chinese herbs, vitamin A and anabolic steroids; no mention of Ba Jiao Lian).
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. (2012). Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, herbal drugs and supplements including 1 publication on Ba Jiao Lian [Kao 1992]).
Bunchorntavakul C, Reddy KR. (2013). Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther. (Systematic review of literature on HDS associated liver injury discusses Chinese and Asian herbs, but does not mention Ba Jiao Lian specifically).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 15 attributed to herbals or dietary supplements, but none to Ba Jiao Lian specifically).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 130 cases of HDS associated liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to Ba Jiao Lian).
Seeff LB, Bonkovsky HL, Navarro VJ, Wang G. (2015). Herbal products and the liver: a review of adverse effects and mechanisms. Gastroenterology. (Extensive review of herbal associated liver injury does not discuss Ba Jiao Lian specifically).
Medina-Caliz I, Garcia-Cortes M, Gonzalez-Jimenez A, Cabello MR, Robles-Diaz M, Sanabria-Cabrera J, Sanjuan-Jimenez R, et al., Spanish DILI Registry. (2018). Herbal and dietary supplement-induced liver injuries in the Spanish DILI Registry. Clin Gastroenterol Hepatol. (Among 856 cases of hepatotoxicity enrolled in the Spanish DILI Registry between 1994 and 2016, 32 were attributed to herbal products, the most frequent cause being green tea [n=8] and Herbalife products [n=6], while none were attributed to Ba Jiao Lian).
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. (2022). Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. (Among 367 cases of hepatotoxicity enrolled in the Latin American DILI Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being green tea [n=7], Herbalife products [n=5] and garcinia [n=3], while none were attributed to Ba Jiao Lian).
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. (2021). Herb-induced liver injury: Systematic review and meta-analysis. World J Clin Cases. (Systematic review of the literature on herb induced liver injury identified 446 references describing 936 cases due to 79 different herbal products, the most common being He Shou Wu [91], green tea [90] Herbalife products [64], kava [62 and greater celandine [48]; only 4 were attributed to Ba Jiao Lian).

## OTHER REFERENCE LINKS

1 Recent References on Ba Jiao Lian: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Ba+Jiao+Lian+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Ba Jiao Lian: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=ba+jiao+lian)